# Fluconazole

## OVERVIEW

### Introduction

Fluconazole is a triazole fungistatic agent used in the treatment of systemic and superficial fungal infections. Fluconazole therapy can cause transient mild-to-moderate serum aminotransferase elevations and is a known cause of clinically apparent acute drug induced liver injury.

### Background

Fluconazole (floo kon' a zole) is a fungicidal agent which inhibits lanasterol-14-α-demethylase, the enzyme responsible for ergosterol synthesis. As a consequence, fluconazole causes an increase in abnormal intracellular sterols, inhibiting the fungal cell’s ability to replicate. Fluconazole was approved for use in the United States in 1990 and currently more than 12 million prescriptions are written for it yearly. Current indications include treatment of fungal infections due to candida and cryptococcus. Fluconazole is available in multiple generic forms and under the brand name Diflucan in tablets of 50, 100, 150 and 200 mg, as well as in oral suspensions and parenteral formulations. The usual recommended dose is 100 to 400 mg daily, depending upon the type and severity of the infection. Common side effects include nausea, vomiting, and headache.

### Hepatotoxicity

Transient mild-to-moderate elevations in serum aminotransferase levels occur in up to 5% of patients treated with fluconazole, but these abnormalities are usually asymptomatic and resolve even with continuation of the medication. ALT elevations above 8 times the upper limit of normal are reported to occur in 1% of patients taking fluconazole and to represent the most common adverse event leading to early discontinuation of treatment. Clinically apparent hepatotoxicity due to fluconazole is rare, but well described. The liver injury is typically hepatocellular, arises within the first few weeks of therapy and can be accompanied by signs of hypersensitivity such as fever, rash and eosinophilia. Fatal instances of fluconazole induced liver injury have been reported (Case 1), but most cases are self-limited, although recovery may be delayed for several weeks after stopping fluconazole and may be slow requiring 2 to 3 months.

Likelihood score: B (likely cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of clinically apparent hepatotoxicity from fluconazole is unknown; however, it may relate to the ability of fluconazole to alter sterol synthesis. Fluconazole is a potent inhibitor of the cytochrome P450 enzyme CYP 3A4, and can lead to significant increases in plasma levels and serious toxicity from medications that are ordinarily metabolized by CYP3A4, particularly the statins and cyclosporine.

### Outcome and Management

The severity of liver injury from fluconazole ranges from mild and transient enzyme elevations to clinically apparent hepatitis to acute liver failure and death. Most patients recover with stopping fluconazole, but resolution may be slow requiring 3 to 4 months. Rechallenge may lead to recurrence and should be avoided. There is little information on cross reactivity of hepatic injury between fluconazole and other antifungal azoles, such as ketoconazole, itraconazole, voriconazole and posaconazole, but a few reports suggest that there is little cross reactivity. Nevertheless, other antifungal azoles should be started with caution in patients who have suffered clinically apparent hepatotoxicity attributed to fluconazole.

Drug Class: Antifungal Agents

## CASE REPORT

### Case 1. Fluconazole induced acute liver failure.

[Modified from: Jacobson MA, Hanks DK, Ferrell LD. Fatal acute hepatic necrosis due to fluconazole. Am J Med 1994; 96: 188-90. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/7677802)]

A 32 year old man with HIV infection, Kaposi's sarcoma and cryptococcal meningitis received a two week course of amphotericin B, followed by oral fluconazole (400 mg daily). Liver tests were monitored and were normal when fluconazole was started. One week later, serum ALT levels had risen, but the patient was asymptomatic. After 21 days of fluconazole therapy, however, he presented with progressive weakness, nausea, jaundice and low grade fever. Both serum bilirubin and ALT levels had risen markedly (Table) and prothrombin time was prolonged at 22.3 seconds. He was admitted for management. He was somnolent and icteric. Tests for hepatitis A and B were negative. His other medications included aerosolized pentamidine, prochlorperazine (for nausea), acetaminophen with codeine (for pain), acetazolamide and cimetidine. He was not receiving antiretroviral therapy. Acetaminophen level was 4 mg/L, which was considered a nontoxic level. Despite supportive therapy, he became progressively more unresponsible and died 4 days later in hepatic failure, 25 days after starting fluconazole. Autopsy showed massive necrosis without viral inclusion bodies or steatosis.

#### Key Points

Medication: | Fluconazole (400 mg daily)
Pattern: | Hepatocellular (R=24)
Severity: | 5+ (acute liver failure and death)
Latency: | 3 weeks
Recovery: | None
Other medications: | Pentamidine, prochlorperazine, acetazolamide, cimetidine, acetaminophen and codeine

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
0 | | 70 | 98 | 1.0 | Fluconazole started
5 days | | 173 | 101 | 0.8
18 days | | 1550 | | 19.0
21 days | 1 day | 1825 | 247 | 13.4 | Fluconazole stopped
22 days | 2 days | 1605 | 222 | 19.0 | Protime 28 sec
23 days | 3 days | 1105 | 190 | 23.5
24 days | 4 days | 780 | 210 | 28.6
Died of fulminant hepatic failure 25 days after starting fluconzole
Normal Values | | <40 | <130 | <1.2

#### Comment

A dramatic example of an acute hepatitis-like syndrome arising within 2 to 3 weeks of starting fluconazole, with rapid progression to acute liver failure and death.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Fluconazole – Generic, Diflucan®

DRUG CLASS

Antifungal Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=fluconazole)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Fluconazole | 86386-73-4 | C13-H12-F2-N6-O | Fluconazole chemical structure

## ANNOTATED BIBLIOGRAPHY

References updated: 21 May 2017

Zimmerman HJ. Antifungal agents. Hormonal derivatives and related drugs. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 609-11. (Expert review of hepatotoxicity of antifungal agents published in 1999 mentions that fluconazole has been implicated in cases of hepatic injury with jaundice).
Moseley RH. Antifungal agents. Antibacterial and antifungal agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 470-81. (Review of hepatotoxicity of antifungal agents ; mentions that asymptomatic elevations in liver enzymes occur in less than 7% of patients treated with fluconazole, but the rate may be higher in patients with HIV infection, and that at least 3 deaths from acute hepatocellular injury have been described).
Bennett JE. Antimicrobial agents: antifungal agents. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1571-92. (Textbook of pharmacology and therapeutics; a fluorinated bistriazole, fluconazole is used for candidiasis and cryptococcosis; it is an inhibitor of CYP 3A4 and CYP 2C9 and may increase plasma levels of several drugs).
Stern JJ, Hartman BJ, Sharkey P, Rowland V, Squires KE, Murray HW, Graybill JR. Oral fluconazole therapy for patients with acquired immunodeficiency syndrome and cryptococcosis: experience with 22 patients. Am J Med 1988; 85: 477-80. (Open label study of fluconazole for 8-64 weeks in 22 patients with AIDS and cryptococcal infection; serum aminotransferase levels became abnormal in four patients [19%]). 2845778
De Wit S, Weerts D, Goossens H, Clumeck N. Comparison of fluconazole and ketoconazole for oropharyngeal candidiasis. Lancet 1989; 1: 746-50. (Randomized trial of fluconazole vs ketoconazole in 37 patients with HIV infection and oropharyngeal candidiasis; ALT or AST elevations occurred in 1 of 18 [6%] on fluconazole vs 4 of 19 [21%] on ketoconazole; fluconazole was also more effective). 2564563
Van Cauteren H, Lampo A, Vandenberghe J, Vanparys P, Coussement W, De Coster R, Marsboom R. Toxicological profile and safety evaluation of antifungal azole derivatives. Mycoses 1989; 32 Suppl 1: 60-6. (Review of toxicity of antifungal azoles from Janssen Research Foundation; itraconazole has less drug-drug interaction and effect on P450 activity in animal models than ketoconazole or fluconazole). 2561186
Franklin IM, Elias E, Hirsch C. Fluconazole-induced jaundice. Lancet 1989; 336: 565. (41 year old man with hemophilia and HIV infection developed jaundice 2 months after starting fluconazole [also on zidovudine, trimethoprim and nystatin] with bilirubin 11.5 mg/dL, AST 950 U/L, Alk P 410 U/L, resolving slowly upon stopping). 1975057
Samonis G, Rolston K, Karl C, Miller P, Bodey GP. Prophylaxis of oropharyngeal candidiasis with fluconazole. Rev Infect Dis 1990; 12 Suppl 3: S369-73. (Controlled trial of 4 weeks of fluconazole vs placebo as antifungal prophylaxis in 112 cancer patients showed that fluconazole was effective in preventing thrush; ALT elevations [108, 114 and 141 U/L] with symptoms or jaundice occurring in 3 of 58 patients on fluconazole [5%], which led to discontinuation in 2). 2184514
Muñoz P, Moreno S, Garau X, Lopez Bernaldo de Quiros JC, Berenguer J, More J, Bouza E. [Multicenter study of fluconazole in the treatment of oropharyngeal candidiasis in immunodepressed patients]. Enferm Infecc Microbiol Clin 1990; 8: 560-4. (Among 27 patients with oropharyngeal candidiasis treated with fluconazole for 1-4 weeks, 3 [11%] developed asymptomatic elevations in serum enzymes after 7 days [ALT 495 and 293 U/L and Alk P 620 and 941 U/L] and 14 days [105 U/L, Alk P 1234 U/L], which resolved within 1-2 weeks of stopping in 2 patients; the other dying 5 days later of disseminated mycobacterium avium). 2099857
Muñoz P, Moreno S, Berenguer J, Bernaldo de Quirós JC, Bouza E. Fluconazole-related hepatotoxicity in patients with acquired immunodeficiency syndrome. Arch Intern Med 1991; 151: 1020-1. (Among 27 immunosuppressed patients given fluconazole for oral-esophageal candidiasis, 3 developed hepatotoxicity; 2 had asymptomatic rises in ALT levels [27→173; 30→293] within 2 weeks of starting and resolution within within 2 weeks of stopping fluconazole; third patient developed jaundice by day 10 [bilirubin 12 mg/dL, ALT 495 U/L, Alk P 923 U/L] and died 5 days later). 2025128
Lee JW, Seibel NL, Amantea M, Whitcomb P, Pizzo PA, Walsh TJ. Safety and pharmacokinetics of fluconazole in children with neoplastic diseases. J Pediatr 1992; 120: 987-93. (26 children with cancer received intravenous fluconazole for fungal prophylaxis for 7 days, 3 developed ALT elevations of 369 to 687 U/L, falling rapidly to normal upon stopping infusions--no symptoms or jaundice). 1593362
Wells C, Lever AM. Dose-dependent fluconazole hepatotoxicity proven on biopsy and rechallenge. J Infect 1992; 24: 111-2. (46 year old man with HIV infection who received multiple courses of fluconazole, developing serum enzyme elevations when dose was increased to 200 mg daily [bilirubin not mentioned, ALT 100-500 U/L, Alk P 300-500 U/L]). 1548414
Hay RJ. Risk/benefit ratio of modern antifungal therapy: focus on hepatic reactions. J Am Acad Dermatol 1993; 29: S50-4. (Review article on hepatotoxicity of antifungal agents, griseofulvin, ketoconazole, fluconazole, itraconazole and terbinafine; does not recommend routine monitoring, but stresses need to discontinue agent for hepatic injury with symptoms). 8315062
Pons V, Greenspan D, Debruin M. Therapy for oropharyngeal candidiasis in HIV-infected patients: a randomized, prospective multicenter study of oral fluconazole versus clotrimazole troches. The Multicenter Study Group. J Acquir Immune Defic Syndr 1993; 6: 1311-6. (Trial of 14 days of fluconazole vs clotrimazole in 334 HIV infected patients with oropharyngeal candidiasis; 2 patients on fluconazole, but none of clotrimazole were withdrawn for serum ALT elevations). 8254467
Gearhart M. Worsening of liver function with fluconazole and review of azole antifungal hepatotoxicity. Ann Pharmacother 1994; 28: 1177-81. (50 year old woman with probable chronic hepatitis C and cirrhosis had acute worsening within a few days of starting fluconazole [bilirubin 1.6 rising to 6.6 mg/dL, AST from 66 to 1556 U/L, protime from 19.2 to 29.8 sec], improving when fluconazole was stopped). 7841574
Trujillo MA, Galgiani JN, Sampliner RE. Evaluation of hepatic injury arising during fluconazole therapy. Arch Intern Med 1994; 154: 102-4. (Two patients developed elevated liver tests 3 and 4 weeks after starting fluconazole, but were able to continue therapy when liver biopsy showed no evidence of hepatocyte necrosis and abnormalities ultimately resolved). 8267481
Jacobson MA, Hanks DK, Ferrell LD. Fatal acute hepatic necrosis due to fluconazole. Am J Med 1994; 96: 188-90. (32 year old man with HIV and cryptococcal meningitis developed jaundice 3 weeks after starting fluconazole with bilirubin 13.4 mg/dL, ALT 1825 U/L and Alk P 247 U/L, and protime 22.3 sec with worsening stupor, coma and hepatic failure dying 4 days later: Case 1). 7677802
Flynn PM, Cunningham CK, Kerkering T, San Jorge AR, Peters VB, Pitel PA, Harris J, et al. Oropharyngeal candidiasis in immunocompromised children: a randomized, multicenter study of orally administered fluconazole suspension versus nystatin. The Multicenter Fluconazole Study Group. J Pediatr 1995; 127: 322-8. (Controlled trial of 14 days of fluconazole vs nystatin in 182 children with oropharyngeal candidiasis; liver test abnormalities occurred in 8% on nystatin vs 7% on fluconazole; no early discontinuations because of abnormalities). 7636666
Guillaume MP, De Prez C, Cogan E. Subacute mitochondrial liver disease in a patient with AIDS: possible relationship to prolonged fluconazole administration. Am J Gastroenterol 1996; 91: 165-8. (28 year old woman with HIV infection developed rising Alk P [to 2018 U/L] without jaundice on long term fluconazole therapy, improving with stopping therapy and recurring on restarting). 8561126
Bronstein JA, Gros P, Hernandez E, Larroque P, Molinié C. Fatal acute hepatic necrosis due to dose-dependent fluconazole hepatotoxicity. Clin Infect Dis 1997; 25: 1266-7. (85 year old man developed severe hepatitis 11 days after starting fluconazole [bilirubin 1.6 rising to 6.3 mg/dL, ALT 3540 U/L, Alk P 213 U/L], progressing to hepatic failure and death; autopsy showed centrolobular necrosis). 9402409
Stevens DA, Diaz M, Negroni R, Montero-Gei F, Castro LGM, Sampaio SAP, Borelli D, et al. and Fluconazole Pan-American Study Group. Safety evaluation of chronic fluconazole therapy. Chemotherapy 1997; 43: 371-7. (Among 93 patients treated with fluconazole for up to several years, ALT elevations occurred in 2 and AST in 9 patients, none symptomatic or requiring discontinuation). 9309372
Lawson CA, Karlowsky JA, Zhanel GG. Fluconazole-induced hepatotoxicity: review of published case reports. Can J Hosp Pharm 1998; 51: 61-3. Not in PubMed
García Rodriguez L, Duque A, Castellsague J, Pérez-Gutthann S, Stricker B. A cohort study on the risk of acute liver injury among users of ketoconazole and other antifungal drugs. Br J Clin Pharmacol 1999; 48: 847-52. (Population based study identified 5 cases of acute liver injury during antifungal therapy in 69,830 patients; relative risk for ketoconazole was 228 [~2:1,000 patients], itraconazole 17.7 [~1:10,000] and terbinafine 4.2 [~.2:10,000]; no cases among 35,833 recipients [29,701 patient-months] of fluconazole). 10594489
Bradbury BD, Jick SS. Itraconazole and fluconazole and certain rare, serious adverse events. Pharmacotherapy 2002; 22: 697-700. (Among 16,001 users of itraconazole and 34,220 users of fluconazole in UK general practice database, only two cases of liver injury were identified, both were anicteric and self-limited; “Itraconazole and fluconazole do not commonly cause rare, serious adverse events affecting the liver...”). 12066960
De Bellis P, Bonfiglio M, Gerbi G, Bacigalup P, Buscaglia G, Guido P, Massobrio B. High-dose fluconazole therapy in Intensive Care Unit. Minerva Anestesiol 2003; 69: 145-52, 153-7. (Open label study of 1- to 2-week courses of fluconazole [800 mg/day] in 378 ICU patients with candida colonization in urine; serum ALT or AST elevations occurred in 10%, but were transient in all cases and there were no cases of clinically apparent hepatitis). 12792583
Schöttker B, Dösch A, Kraemer D. Severe hepatotoxicity after application of desloratadine and fluconazole. Acta Haematol 2003; 110: 43-44. (38 year old woman with lymphoma and bone marrow transplant developed acute serum enzyme elevations 2 days after starting intravenous fluconazole and while on meropenem, desloratadine, allopurinol, ranitidine, larcepam, clemastine and spironolactone [bilirubin 1.2 mg/dL, ALT 871 U/L, Alk P 290 U/L, LDH 5010 U/L], with recovery within 8 days of stopping, resembling ischemic injury more than hepatitis). 12975558
Kim H, Bindslev-Jensen C. Reported case of severe hepatotoxicity likely due to fluconazole and not desloratadine. Acta Haematol 2004; 112: 177-8. (Letter concerning report by Schottker et al. [2003] arguing that the cause of the injury was fluconazole and not desloratadine, based upon timing and literature). 15345904
Su FW, Perumalswami P, Grammer LC. Acute hepatitis and rash to fluconazole. Allergy 2003; 58: 1215-6. (39 year old man took 2 doses of fluconazole 1 week apart and developed jaundice, fever and rash with eosinophilia [bilirubin 31.5 mg/dL, ALT 4192 U/L, Alk P 141 U/L], resolved on prednisone within 3 months). 14616149
Linnebur SA, Parnes BL. Pulmonary and hepatic toxicity due to nitrofurantoin and fluconazole treatment. Ann Pharmacother 2004; 38: 612-6. (73 year old man developed ALT elevations and symptoms of fatigue, 8 weeks after starting fluconazole, but also 5 years after starting nitrofurantoin, abnormal tests resolving in 4 weeks of stopping both). 14966256
Wingfield AB, Fernandez-Obregon AC, Wignall FS, Greer DL. Treatment of tinea imbricate: a randomized clinical trial using griseofulvin, terbinafine, itraconazole and fluconazole. Br J Dermatol 2004; 150: 119-26. (Randomized trial of four antifungals for 4 weeks for tinea imbricate in 86 patients in New Guinea; griseofulvin and terbinafine were effective; itraconazole and fluconazole were not; only one patient had ALT elevation [3 fold: terbinafine]). 14746625
Fischer MA, Winkelmayer WC, Rubin RH, Avorn J. The hepatotoxicity of antifungal medications in bone marrow transplant recipients. Clin Infect Dis 2005; 41: 301-7. (Among 438 patients undergoing bone marrow transplantation, 123 developed ALT or AST above 3 times ULN; factors associated with significant increases were liposomal amphotericin [Odds Ratio = 3.8] and fluconazole [2.6], but not standard amphotericin [2.0]). 16007524
Wingard J, Leather H. Hepatotoxicity associated with antifungal therapy after bone marrow transplantation. Clin Infect Dis 2005; 41: 308-10. (Editorial accompanying article by Fischer et al. [2005] discussing difficulty of diagnosis of drug induced liver disease in patients after bone marrow transplant). 16007525
Song J, Deresinski S. Hepatotoxicity of antifungal agents. Curr Opin Investig Drugs 2005; 6: 170-7. (Extensive review of hepatotoxicity from antifungals; fluconazole causes ALT elevations greater than 8-fold normal in 1% of patients, but clinically apparent liver injury is rare; 7 cases of self-limited and 4 cases of fatal acute liver disease attributed to fluconazole have been described; onset usually in 10-21 days). 15751740
Cruciani M, Mengoli C, Malena M, Bosco O, Serpelloni G, Grossi P. Antifungal prophylaxis in liver transplant patients: a systematic review and meta-analysis. Liver Transpl 2006; 12: 850-8. (Metaanalysis found 6 studies with total of 698 patients comparing fluconazole, itraconazole or amphotericin vs placebo for prevention of fungal infections after liver transplantation; side effects were more with prophylaxis; liver toxicity was not discussed). 16628697
Girois SB, Chapuis F, Decullier E, Revol BG. Adverse effects of antifungal therapies in invasive fungal infections: review and meta-analysis. Eur J Clin Microbiol Infect Dis 2006; 25: 138-49. (Systematic review of adverse effects of antifungal therapy in 54 studies with 9228 patients; hepatotoxicity reported in 14.1-18.6% on amphotericin, 1.9% on fluconazole and 31.6% on itraconazole, but great variation in definitions and intensity of monitoring). 16622909
Aghai ZH, Mudduluru M, Nakhla TA, Amendolia B, Longo D, Kemble N, Kaki S. Fluconazole prophylaxis in extremely low birth weight infants: association with cholestasis. J Perinatol 2006; 26: 550-5. (Intravenous fluconazole prophylaxis in low birth weight infants reduced rate of invasive candidiasis from 6.6% [historical controls] to 0%, but increased direct and total hyperbilirubinemia from 9% to 43%, but no difference in average ALT or AST or rate of elevations above 250 U/L). 16940972
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, two cases were attributed to fluconazole, one to ketoconazole, one to itraconazole, none to voriconazole). 18955056
Björnsson E, Davidsdottir L. The long-term follow-up after idiosyncratic drug-induced liver injury with jaundice. J Hepatol 2009; 50: 511-7. (In long term follow up of 685 patients with drug induced liver injury in Sweden, 8 were found to have developed cirrhosis, 5 of whom died including a 34 year old man with fluconazole hepatotoxicity who died 4 years later of complications of cirrhosis, possibly alcoholic). 19155082
Antifungal drugs. Treat Guidel Med Lett 2009; 7: 95-102. (Concise summary of therapy of fungal infections with recommendations on agents to be used, dosage and duration of treatment and safety; fluconazole is active against most Candida species and both coccidioides and cryptococcus, but not aspergillus; Stevens-Johnson syndrome, anaphylaxis and hepatic toxicity have been reported). 19940816
Wang JL, Chang CH, Young-Xu Y, Chan KA. Systematic review and meta-analysis of the tolerability and hepatotoxicity of antifungals in empirical and definitive therapy for invasive fungal infection. Antimicrob Agents Chemother 2010; 54: 2409-19. (Systematic review of 39 controlled trials in more than 8000 patients, found liver enzyme elevations in 10% of patients on fluconazole, but only 0.7% needed to stop therapy; rate for itraconazole was 18.9%, voriconazole 19.7%). 20308378
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol 2010; 70: 721-8. (Worldwide pharmacovigilance database contained 9036 hepatic adverse drug reactions in children, voriconazole ranked 21st with 52 cases [odds ratio 10.7] and fluconazole 30th with 42 cases [odds ratio 8.6]; no other antifungal agent listed in the top 41 causes). 21039766
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, of which 6 were caused by antifungal agents including 3 attributed to terbinafine, 2 to ketoconazole, 1 to itraconazole, but none to fluconazole). 20949552
Devarbhavi H, Dierkhising R, Kremers WK, Sandeep MS, Karanth D, Adarsh CK. Single-center experience with drug-induced liver injury from India: causes, outcome, prognosis, and predictors of mortality. Am J Gastroenterol 2010; 105: 2396-404. (Among 313 cases of drug induced liver injury seen over a 12 year period at a large hospital in Bangalore, India, one was attributed to fluconazole). 20648003
Egunsola O, Adefurin A, Fakis A, Jacqz-Aigrain E, Choonara I, Sammons H. Safety of fluconazole in paediatrics: a systematic review. Eur J Clin Pharmacol 2013; 69: 1211-21. (Systematic review of 90 published articles on side effects of fluconazole in 4209 children or neonates, found hepatotoxicity to be the most common adverse event [378 cases, about half of adverse events], but most were self-limited represented by elevated liver enzymes only). 23325436
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, none of which were attributed to fluconazole or other antifungal agents). 23419359
Kao WY, Su CW, Huang YS, Chou YC, Chen YC, Chung WH, Hou MC, et al. Risk of oral anti-fungal agent-induced liver injury in Taiwanese. Br J Clin Pharmacol 2014; 77: 180-9. (Analysis of Taiwan National Health Insurance database from 2002-2008 identified 52 patients with drug induced liver injury among 90,847 users of oral antifungal agents, rates were 32 per 10,000 persons for fluconazole [12 cases, 6 of which were fatal]). 23750489
Kurt H, Toprak O, Bülbül E. The possible efficacy of artichoke in fluconazole related hepatotoxicity. Case Reports Hepatol 2014; 2014: 697359. (40 year old woman with multiple sclerosis received 10 days of intravenous methylprednisolone and then a single tablet of fluconazole, developing symptoms of liver injury over the next 5-12 days [bilirubin 5.2 mg/dL, ALT 1180 U/L, Alk P 85 U/L, INR 1.38], bilirubin rising to 36 mg/dL, but resolving over next 2 months while taking artichoke leaf tea 3 times daily). 25374729
Raschi E, Poluzzi E, Koci A, Caraceni P, Ponti FD. Assessing liver injury associated with antimycotics: Concise literature review and clues from data mining of the FAERS database. World J Hepatol 2014; 6: 601-12. (Analysis of the FDA database on adverse reactions [2004 to 2011] identified 68,115 reports of liver injury including 1964 due to antifungal agents, the most common being terbinafine [422], fluconazole [412], voriconazole [361], amphotericin B [265], itraconazole [182], ketaconazole [94] and posaconazole [70]; among 112 cases with acute liver failure with, the major causes were fluconazole [31], terbinafine [27], and voriconazole [19]). 25232453
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 14 cases [1.6%] were attributed to antifungal agents including 6 triazoles [3 with jaundice and 2 hospitalized, no deaths], 4 due to fluconazole, 1 ketoconazole and 1 voriconazole). 25754159
Lo Re V 3rd, Carbonari DM, Lewis JD, Forde KA, Goldberg DS, Reddy KR, Haynes K, et al. Oral azole antifungal medications and risk of acute liver injury, overall and by chronic liver disease status. Am J Med 2016; 129: 283-91. (Among 178,879 persons treated with oral fluconazole analyzed from a Kaiser Permanente clinical database, the incidence of ALT or AST elevations above 200 U/L was 1.3% and severe acute liver injury 0.2%; rates that were similar to those with ketoconazole and less than for posaconazole and vorconazole). 26597673
Kyriakidis I, Tragiannidis A, Munchen S, Groll AH. Clinical hepatotoxicity associated with antifungal agents. Expert Opin Drug Saf 2017; 16: 149-65. (Review of the hepatotoxicity of antifungal agents states that all antifungal agents may cause hepatic toxicity and discusses fluconazole, itraconazole, voriconazole, posaconazole and isavuconazole, but not ketoconazole). 27927037

## OTHER REFERENCE LINKS

1. Recent References on Fluconazole: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(fluconazole)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%222010/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. : from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=fluconazole) Trials on Fluconazole: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=fluconazole)